# Hydromorphone

## OVERVIEW

### Introduction

Hydromorphone and oxymorphone are semisynthetic derivatives of morphine and potent opiate agonists which are used predominantly to treat moderate-to-severe pain. Neither hydromorphone nor oxymorphone have been linked to serum enzyme elevations during therapy or to clinically apparent liver injury.

### Background

Hydromorphone and oxymorphone are semisynthetic derivatives that both act by engagement in cell surface opiate receptors (predominant µ type receptors) that are found in the central nervous system, but also heart, lung, vascular and intestinal cells. Current indications are for moderate-to-severe pain, pre- and postoperative analgesia, and as an adjunct to anesthesia.

Hydromorphone was approved for use in the United States in 1984 and is still widely used in treatment of moderate-to-severe pain not responsive to non-opioid agents. Hydromorphone is also used, in low doses, as an antitussive. Hydromorphone is available generically and under the brand name Dilaudid as tablets of 2, 4 and 8 mg, as an oral solution of 5 mg/5 mL and as suppositories of 3 mg. Extended release tablets of 8, 16, 24 and 32 mg are available for treatment of chronic pain in opioid-tolerant subjects who have severe pain requiring around-the-clock opioid therapy. Solutions for injection (1 to 10 mg/mL) are also available. The usual dose of hydromorphone for acute pain in adults is 2 to 10 mg orally every 3 to 6 hours or 2 to 4 mg by injection every 4 to 6 hours. Lower doses (1 mg orally) are used for treatment of cough.

Oxymorphone was approved for use in the United States in 1959 and remains in clinical use. Current indications are for treatment of moderate-to-severe pain, alleviation of anxiety associated with dyspnea of pulmonary edema and as an adjunct to general anesthesia and preoperative sedation. Oxymorphone is available generically and under the brand name Numorphan and Opana in standard tablets of 5 and 10 mg, suppositories of 5 mg and as a solution for injection of 1 mg/mL. Extended release tablets of 5 to 40 mg are available for use in opioid-tolerant patients with pain severe enough to require around-the-clock opioids. The usual dose of oxymorphone is 5 to 20 mg orally of the standard tablets every 4 to 6 hours or 1 to 1.5 mg by injection every 4 to 6 hours.

The side effects of hydromorphone and oxymorphone are similar to those of other opiates and include sedation, respiratory depression, confusion, euphoria, agitation, constipation, abdominal bloating, nausea, vomiting and constipation. Both drugs are controlled substances and classified as Schedule II drugs, indicating that they have medical usefulness, but also a high potential for physical and psychological dependency and abuse. Severe adverse events include life-threatening respiratory depression, addiction, abuse, opioid withdrawal, serotonin syndrome (when used with serotonergic agents) and adrenal insufficiency.

### Hepatotoxicity

As with most opiates in current use, therapy with hydromorphone and oxymorphone has not been linked to serum enzyme elevations. There have been no convincing cases of idiosyncratic acute, clinically apparent liver injury attributed to either agent.

Likelihood score, Hydromorphone: E (unlikely cause of clinically apparent liver injury).

Likelihood score, Oxymorphone: E (unlikely cause of clinically apparent liver injury).

References on the safety and potential hepatotoxicity of hydromorphone and oxymorphone are given in the Overview section of the Opioids.

Drug Class: Opioids

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Hydromorphone – Generic, Dilaudid®

Oxymorphone – Generic, Numorphan®, Opana®

DRUG CLASS

Opioids

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Hydromorphone) (Hydromorphone)

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Oxymorphone) (Oxymorphone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Hydromorphone | 466-99-9 | C17-H19-N-O3
Oxymorphone | 76-41-5 | C17-H19-N-O4

## OTHER REFERENCE LINKS

1 Recent References on Hydromorphone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Hydromorphone+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Hydromorphone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Hydromorphone)
3 Recent References on Oxymorphone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Oxymorphone+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
4 Trials on Oxymorphone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Oxymorphone)